# Insulin

## OVERVIEW

### Introduction

Insulin is a pancreatic hormone that plays an essential role in regulation of blood glucose as well as lipid and carbohydrate metabolism. Both natural and recombinant forms of insulin are used therapeutically to treat type 1 diabetes. While insulin itself is not hepatotoxic and has not been linked to serum enzyme elevations or instances of clinically apparent liver injury, high doses including overdoses of insulin and glucose can result in hepatic glycogenosis and serum aminotransferase elevations.

### Background

Insulin (in' su lin) is a polypeptide hormone produced by pancreatic islet β cells that is primarily responsible for regulation of blood glucose and storage of carbohydrates and lipids. Type 1 diabetes is due to inadequate production of insulin caused by destruction and loss of insulin producing pancreatic islet β cells. Type 2 diabetes is due to relative insulin resistance. Initial forms of insulin were isolated from pancreas tissue harvested from swine and cattle, and thus referred to as pork and beef insulins. More recently, human insulins have been produced by recombinant techniques. Since its first use in the 1930s, insulin has been the mainstay of therapy of type 1 diabetes. Insulin is also used in patients with type 2 diabetes that is refractory to lifestyle interventions (diet, physical activity, weight loss) and use of oral hypoglycemic agents. Multiple formulations of insulin are available including short-acting (regular), rapid-acting (aspart, glulisine, lispro) and medium- or long-acting (NPH, glargine, detemir) forms generically and under brand names such as Apidra, Basaglar, Humalog, Humulin, Lantus, Levemir, Novolin, Novolog and Tresiba. Commercial combination products with several forms of insulin or insulin with other agents are also available. Insulin can be given intravenously, intramuscularly and subcutaneously and the dose and frequency of administration varies by formulation and the individual being treated. Adverse events from insulin are largely due to hypoglycemia. Insulin therapy often results in weight gain. Local injection reactions (lipoatrophy) and hypersensitivity reactions are uncommon, particularly with newer recombinant forms of insulin.

### Hepatotoxicity

Insulin in typical therapeutic doses is not associated with serum enzyme elevations or with episodes of clinically apparent liver injury. However, use of insulin in poorly controlled type 1 diabetes can result in a clinical syndrome known as glycogenosis or glycogenic hepatopathy, marked by varying degrees of hepatomegaly, abdominal pain and serum aminotransferase elevations. Serum ALT and AST levels range from normal to 20 to 30 times the upper limit or normal. Alkaline phosphatase and bilirubin levels are minimally increased or normal. Serum glucose and hemoglobin A1c levels are invariably elevated, and the liver and metabolic abnormalities resolve rapidly with better glycemic control. A severe form of glycogenosis associated with hepatomegaly, growth retardation, delayed puberty and Cushingoid facies in children is known as Mauriac syndrome. Glycogenosis with serum enzyme elevations can also occur in patients with insulin overdose during treatment with high doses of intravenous glucose (Case 1). Glycogenosis has also been reported in patients recieving short-term, high-dose corticosteroids..

The diagnosis of glycogenosis can be confirmed by liver biopsy which typically shows slightly swollen hepatocytes with pale cytoplasm and accentuated cell membranes, which with periodic acid Schiff (PAS) staining demonstrates intracytoplasmic accumulation of glycogen. Imaging by CT usually shows an enlarged and hyper-dense liver in contrast to hepatic steatosis which generally causes a hypo-dense pattern. The condition can be relapsing, accompanying repeated episodes of hyperglycemia, but it does not appear to result in chronic liver injury, fibrosis or cirrhosis. Thus, the serum enzyme elevations are due to the combination of marked hyperglycemia and intermittent or high levels of insulin and not to intrinsic hepatotoxicity or an idiosyncratic reaction to insulin. The syndrome occurs most commonly in children or young adults with poorly controlled type 1 diabetes.

Likelihood score: A[H] (known cause of liver injury, but only when administered in high or intermittent doses and in the presence of hyperglycemia).

### Mechanism of Liver Injury

Insulin acts to increase uptake of glucose in the liver, decreasing gluconeogenesis and promoting glycogen synthesis. Thus, the hyperglycemia in the presence of high doses of insulin cause excessive production and storage of glycogen in the liver. Glycogenosis can cause serum enzyme elevations, but does not seem to injure hepatocytes and is not associated with permanent liver damage or fibrosis. Glycogenosis reverses rapidly when insulin and glucose are discontinued. Glycogenosis can also result from hyperglycemia caused by high doses of corticosteroids.

### Outcome and Management

The liver injury associated with insulin use or overdose is likely due to glycogenosis rather than inherent injury from insulin, and reverses rapidly when insulin and glucose are discontinued.

Drug Class: Hormonal Agents; Antidiabetic Agents

## CASE REPORT

### Case 1. Hepatic glycogenosis developing after overdose of insulin and high doses of intravenous glucose.

[Modified from: Tsujimoto T, Takano M, Nishiofuku M, Yoshiji H, Matsumura Y, Kuriyama S, Uemura M, et al. Rapid onset of glycogen storage hepatomegaly in a type-2 diabetic patient after a massive dose of long-acting insulin and large doses of glucose. Intern Med 2006; 45: 469-73. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16679704)]

A 41 year old man with poorly controlled type 2 diabetes took an overdose of insulin (~180 units) and was admitted to hospital in coma with severe hypoglycemia (glucose 9 mg/dL). He was given continuous infusions of glucose, but hypoglycemia persisted for 36 hours. On day 3 after admission he developed upper abdominal pain and was found to have tender hepatomegaly and marked elevations in serum enzymes with ALT 1024 U/L, AST 1064 U/L, LDH 1751 U/L, alkaline phosphatase 202 U/L, GGT 181 U/L and total bilirubin 2.3 mg/dL. His serum enzymes had been normal on admission immediately after the overdose (Table). Abdominal CT scanning demonstrated marked hepatomegaly and increased attenuation (hyper-dense liver compared to spleen and kidneys). A liver biopsy showed glycogenosis with minimal cellular infiltration and no necrosis, mild steatosis and no fibrosis. The presence of glycogen was documented by PAS staining with and without diastase. Doses of glucose were decreased and he was switched to oral intake only. Serum enzymes improved rapidly and were normal 2 weeks later. Repeat CT scanning showed a decrease in liver size and in hepatic attenuation. Repeat liver biopsy showed slight ballooning of hepatocytes and minimal residual intracytoplasmic glycogen accumulation.

#### Key Points

Medication: | Insulin glargine overdose treated with glucose infusions
Pattern: | Hepatocellular (R=~16.5)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 3 days
Recovery: | 2 weeks
Other medications: | Voglibose (alpha glucosidase inhibitor)

#### Laboratory Values

Time After Overdose (days) | Therapy | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
1 | iv Glucose [326 g] | 23 | 125 | 0.4 | Coma
2 | iv Glucose [811 g] | 18
3 | iv Glucose [926 g] | 1064 | 202 | 2.3 | Abdominal Pain
4 | iv Glucose [531 g] | 708
5 | iv Glucose [200 g] | 274 | | | Liver biopsy (1)
6 | iv Glucose [52 g] | 214
7 | Oral intake only | 135
10 | | 41
14 | | 24
18 | | 16
21 | | 19 | | | Liver biopsy (2)
Standard Normal Values | | <40 | <130 | <1.2

#### Comment

The sudden onset of hepatomegaly with abdominal pain and marked serum aminotransferase elevations within days of starting glucose infusions after an overdose of insulin is typical of acute glycogenosis and dramatically demonstrates how rapidly the condition can develop and how rapidly it resolves. The clinical features resemble those of the hepatic glycogenosis that occurs in poorly controlled type 1 diabetes when insulin is being administered at a time that significant hyperglycemia is present. The diagnosis can be made based upon the clinical history and the finding of a hyper-dense liver by CT scanning. However, similar serum enzyme elevations can occur due to shock or ischemia and some degree of liver test abnormalities are common in patients with diabetes and fatty liver. The histologic findings of slightly swollen hepatocytes with pale cytoplasm and accentuation of plasma membranes suggests glycogenosis, which can be proven by PAS staining with and without diastase (an enzyme that digests glycogen demonstrating that the PAS-positive granules are composed of glycogen). Thus, insulin is not the direct cause of the liver abnormalities, but does allow for the excess circulating glucose to be taken up by hepatocytes producing amounts of intracytoplasmic glycogen that cause hepatocyte swelling, liver enlargement and release of hepatic enzymes.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Insulin – Generic, Lantus, Humulin®

DRUG CLASS

Hormonal Agents; Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=insulin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Insulin | 11061-68-0 | C257-H383-N65-O77-S6 | Insulin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 April 2018

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of liver injury due to medications published in 1999; does not discuss insulin).
Kleiner DE. Histopathological evaluation of drug-induced liver disease. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd edition. Amsterdam: Elsevier, 2013, pp. 241-63. (Multi-authored text book on drug induced liver injury discusses the histologic features of glycogenosis that can occur in type 1 diabetes and in patients receiving high doses of corticosteroids).
Powers AC, D’Alessio D. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1237-73. (Textbook of pharmacology and therapeutics).
Mauriac P. Gros ventre, hepatomegalie, troubles de las croissance chez les enfants diabetiques traits depuis plusieurs annes par l’insuline. Gaz Hebd Med Bordeaux 1930; 26: 402-10. Not in PubMed (Initial description of “Mauriac syndrome” occurring in children with type 1 diabetes on insulin therapy and marked by hepatomegaly, cushingoid features, growth retardation, delay in puberty and hepatic glycogenosis).
Goodman JI. Hepatomegaly and diabetes mellitus. Ann Intern Med 1953; 39: 1077-87. (Among 459 diabetic patients examined carefully by percussion, 9% with stable diabetes had hepatomegaly compared to 60% with uncontrolled diabetes and 100% with ketoacidosis, usually ascribed to fatty liver or cirrhosis). 13105180
Kaminer Y, Robbins DR. Attempted suicide by insulin overdose in insulin-dependent diabetic adolescents. Pediatrics 1988; 81: 526-8. (13- and 16-year old girls with insulin dependent diabetes attempted suicide with overdoses of insulin [150 and 600 units] and recovered with conservative management; no mention of liver test abnormalities). 3281128
Chatila R, West AB. Hepatomegaly and abnormal liver tests due to glycogenosis in adults with diabetes. Medicine (Baltimore) 1996; 75: 327-33. (Clinical descriptions of 8 adults and 3 children with poorly controlled diabetes and hepatic glycogenosis manifested by hepatomegaly [7 patients, 3 with tenderness] and serum ALT [45-910 U/L] and Alk P [1-10 times ULN] elevations, but normal bilirubin levels, liver biopsies showing glycogenosis, resolving rapidly with diabetes control). 8982149
Shimizu H, Ohtani KI, Kudoh T, Tsuchiya T, Takahashi H, Sato N, Iriuchijima T, et al. Possible liver damage by biosynthetic human insulin. Diabetes Obes Metab 1999; 1: 179-80. (Two patients, ages 53 and 51 years with type 2 diabetes developed liver test abnormalities shortly after starting a recombinant human insulin produced in yeast [Penfill] [ALT 330 U/L and 213 U/L], which fell to normal on stopping and did not increase on switching to an E. coli derived recombinant insulin [Humacart R]). 11220297
Munns CF, McCrossin RB, Thomsett MJ, Batch J. Hepatic glycogenosis: reversible hepatomegaly in type 1 diabetes. J Paediatr Child Health 2000; 36: 449-52. (Three adolescents with poorly controlled type 1 diabetes presented with hepato-splenomegaly and elevations in ALT [135, 147 and 316 U/L] and HgA1c [12.2-14.1], but normal bilirubin and Alk P, all 3 children improving rapidly with better glycemic control). 11036799
Jolliet P, Leverve X, Pichard C. Acute hepatic steatosis complicating massive insulin overdose and excessive glucose administration. Intensive Care Med 2001; 27: 313-6. (48 year old woman who injected 2000 IU of insulin in a suicide attempt and was admitted to a hospital in coma, developed abdominal pain and ALT elevations by day 3 of intravenous glucose infusions [ALT rising from normal to 610 U/L, Alk P 178 U/L, and bilirubin 8.7 mg/dL], with rapid resolution on stopping glucose infusions; assumed to be fatty liver, but without histologic confirmation). 11280657
von Mach MA, Meyer S, Omogbehin B, Kann PH, Weilemann LS. Epidemiological assessment of 160 cases of insulin overdose recorded in a regional poisons unit. Int J Clin Pharmacol Ther 2004; 42: 277-80. (Among 160 cases of insulin overdose, 89% were of suicidal intent, 5% accidental; full recovery occurred in 95%, 2.7% died, 2.7% had residual neurological deficits). 15176650
Tsujimoto T, Takano M, Nishiofuku M, Yoshiji H, Matsumura Y, Kuriyama S, Uemura M, et al. Rapid onset of glycogen storage hepatomegaly in a type-2 diabetic patient after a massive dose of long-acting insulin and large doses of glucose. Intern Med 2006; 45: 469-73. (A 41 year old man with type 2 diabetes developed marked serum ALT and AST elevations 2-3 days after admission for hypoglycemia due to an overdose of insulin glargine [180 units] and while receiving intravenous glucose [ALT rising from 23 to 1024 U/L, ALK P 125 to 202 U/L, bilirubin 0.4 to 2.3 mg/dL], liver biopsy showing glycogenosis, abnormalities resolving within 1-2 weeks: Case 1). 16679704
Torbenson M, Chen YY, Brunt E, Cummings OW, Gottfried M, Jakate S, Liu YC, Yeh MM, Ferrell L. Glycogenic hepatopathy: an underrecognized hepatic complication of diabetes mellitus. Am J Surg Pathol 2006; 30: 508-13. (Among 14 cases of hepatic glycogenosis, all had diabetes and poor glycemic control, ages 8-34 years, ALT levels varying [normal to 1544 U/L], Alk P mildly elevated in 6, hepatomegaly, abdominal pain and nausea in most, biopsies showing cytoplasmic glycogen and minimal fat, responding to glycemic control). 16625098
Mahesh S, Karp RJ, Castells S, Quintos JB. Mauriac syndrome in a 3-year-old boy. Endocr Pract 2007; 13: 63-6. (A 3 year old boy with poorly controlled type 1 diabetes presented with protuberant abdomen, growth impairment, hepatomegaly and liver test abnormalities [ALT 146 U/L, HgA1c 14.2%], and liver, growth and metabolic features improved with better glycemic control). 17360304
Cuthbertson DJ, Brennan G, Walsh S, Henry E. Hepatic glycogenosis: abnormal liver function tests in Type 1 diabetes. Diabet Med 2007; 24: 322-3. (A 19 year old woman on insulin for type 1 diabetes developed ketoacidosis and was found to have hepatomegaly and abnormal liver tests [bilirubin 0.4 mg/dL, ALT 205 U/L, Alk P 132 U/L, HgA1c 12.2%], biopsy showing glycogenosis). 17305792
Sayuk GS, Elwing JE, Lisker-Melman M. Hepatic glycogenosis: an underrecognized source of abnormal liver function tests? Dig Dis Sci 2007; 52: 936-8. (Two patients, ages 19 and 36 years, with type 1 diabetes on insulin with persistently abnormal liver tests [bilirubin normal, ALT 33-49 and 366-844 U/L, Alk P 137-147 and 326-428 U/L, HbA1c 8.1%-9.5%] were found to have glycogenosis on liver biopsy). 17342391
Abaci A, Bekem O, Unuvar T, Ozer E, Bober E, Arslan N, Ozturk Y, Buyukgebiz A. Hepatic glycogenosis: a rare cause of hepatomegaly in Type 1 diabetes mellitus. J Diabetes Complications 2008; 22: 325-8. (A 16 year old boy on insulin for type 1 diabetes developed hepatomegaly and abnormal liver tests [bilirubin 0.8 mg/dL, ALT 58 U/L, GGT 91 U/L, HbA1c 11%] and glycogenosis and steatosis on liver biopsy, resolving with better glycemic control). 18413182
Guclu M, Ersoy C, Imamoglu S. Suicide attempt of a physician with 3600 units of insulin and rapid onset acute hepatitis. Intern Med J 2009; 39: e5-7. (A 29 year old man with type 1 diabetes admitted for an insulin overdose [3600 units] developed sudden ALT and AST elevations 5 days after admission and starting glucose infusions [ALT rising from normal to 1010 U/L], resolving within a week of stopping glucose]. 20233236
van den Brand M, Elving LD, Drenth JP, van Krieken JH. Glycogenic hepatopathy: a rare cause of elevated serum transaminases in diabetes mellitus. Neth J Med 2009; 67: 394-6. (A 29 year old woman on insulin for type 1 diabetes developed hepatomegaly and fluctuating serum ALT levels [peak values ~1500 U/L] with glycogenosis on liver biopsy and improvement with better glycemic control). 20009116
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to troglitazone, but none were attributed to insulin or other antidiabetic medications). 20949552
Sweetser S, Kraichely RE. The bright liver of glycogenic hepatopathy. Hepatology 2010; 51: 711-2. (A 27 year old man with poorly controlled type 1 diabetes developed abdominal pain, hepatomegaly and abnormal liver tests [bilirubin 1.7 mg/dL, ALT 2549 U/L, Alk P 529 U/L, HgA1c 15%], with an enlarged and hyper-dense liver on CT and glycogenosis without fat or fibrosis on liver biopsy, resolving within 3 months with better glycemic control). 19957373
Warriner D, Debono M, Gandhi RA, Chong E, Creagh F. Acute hepatic injury following treatment of a long-acting insulin analogue overdose necessitating urgent insulin depot excision. Diabet Med 2012; 29: 232-5. (A 26 year old man with type 1 diabetes developed marked abdominal pain and liver test abnormalities [ALT rising from 11 to 520 U/L, Alk P 98 to 203, bilirubin 0.7 to 1.0 mg/dL] 3 days after starting intravenous glucose for hypoglycemia caused by subcutaneous injection of 10 cartridges of glargine insulin, ultimately requiring surgical removal of cartridges). 21781150
Imtiaz KE, Healy C, Sharif S, Drake I, Awan F, Riley J, Karlson F. Glycogenic hepatopathy in type 1 diabetes: an underrecognized condition. Diabetes Care 2013; 36: e6-7. (A 19 year old woman with type 1 diabetes and poor glycemic control was found to have tender hepatomegaly during treatment of ketoacidosis [bilirubin not given, ALT 199 U/L, Alk P 139 U/L, HbA1c 14.6%], biopsy showing glycogenosis without fat or fibrosis). 23264308
Cha JH, Ra SH, Park YM, Ji YK, Lee JH, Park SY, Baik SK, et al. Three cases of glycogenic hepatopathy mimicking acute and relapsing hepatitis in type I diabetes mellitus. Clin Mol Hepatol 2013; 19: 421-5. (Three patients with type 1 diabetes, ages 20-26 years, were referred for evaluation of liver test abnormalities [ALT 169, 213 and 346 U/L, Alk P 346, 189 and 132 U/L, bilirubin 0.5, 0.5 and 0.2 mg/dL, HgA1c 13.8%, 12.9% and 13.6%], liver biopsies showing glycogenosis, liver tests improving, but fluctuating during follow up). 24459648
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to insulin or other antidiabetic medications). 23419359
Dias J, Martins S, Carvalho S, Marques O, Antunes A. Mauriac syndrome still exists. Endocrinol Nutr 2013; 60: 245-8. (Among 91 children with type 1 diabetes followed in a Portuguese pediatric endocrine clinic between 2005 and 2011, 6 had Mauriac syndrome, ages 13-17 years with known diabetes for 4-14 years, all had elevations in HbA1c, 5 had cushingoid features and delayed puberty, 5 hepatomegaly and ALT elevations [64 to 684 U/L]; and in follow up, improved glycemic control was difficult to achieve and clinical improvement varied). 23540612
Fitzpatrick E, Cotoi C, Quaglia A, Sakellariou S, Ford-Adams ME, Hadzic N. Hepatopathy of Mauriac syndrome: a retrospective review from a tertiary liver centre. Arch Dis Child 2014; 99: 354-7. (Retrospective survey from a large pediatric center in London identified 31 children with suspected Mauriac syndrome over a 10 year period, average age 15 years, 48% boys, mean ALT 76 U/L, and liver biopsies in 19 children showed glycogenosis is all). 24412980
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18] and nitrofurantoin [n=17]; no case was attributed to insulin or other antidiabetic medications). 24552865
Giordano S, Martocchia A, Toussan L, Stefanelli M, Pastore F, Devito A, Risicato MG, et al. Diagnosis of hepatic glycogenosis in poorly controlled type 1 diabetes mellitus. World J Diabetes 2014; 5: 882-8. (Review of the pathophysiology, clinical features, diagnosis and management of hepatic glycogenosis). 25512791
Martin J, Tomlinson P. Hepatic complications in poorly controlled type 1 diabetes mellitus: a case report. N Z Med J 2014; 127: 95-7. (13 year old boy with poorly controlled type 1 diabetes developed rising serum aminotransferase levels shortly after an episode of diabetic ketoacidosis, biopsy showing glycogenic hepatopathy, perhaps complicated by ischemic hepatitis). 24806252
Parmar N, Atiq M, Austin L, Miller RA, Smyrk T, Ahmed K. Glycogenic hepatopathy: thinking outside the box. Case Rep Gastroenterol 2015; 9: 221-6. (21 year old woman with poorly controlled type 1 diabetes [HbA1c 13.3%] developed tender hepatomegaly [ALT 590 U/L, AST 3161 U/L, bilirubin and Alk P normal] and ultrasound suggested fatty liver, but biopsy showed glycogenosis and better control of diabetes was followed by fall of serum enzymes to normal). 26269698
Irani NR, Venugopal K, Kontorinis N, Lee M, Sinniah R, Bates TR. Glycogenic hepatopathy is an under-recognised cause of hepatomegaly and elevated liver transaminases in type 1 diabetes mellitus. Intern Med J 2015; 45: 777-9. (19 year old man with poorly controlled type 1 diabetes developed nausea and tender hepatomegaly [bilirubin 0.6 mg/dL, ALT 345 rising to 1180 U/L, Alk P 145 U/L, INR 1.0], biopsy showing glycogenosis, and symptoms and enzymes improving with better diabetic control). 26134697
Jung IA, Cho WK, Jeon YJ, Kim SH, Cho KS, Park SH, Jung MH, Suh BK. Hepatic glycogenosis in type 1 diabetes mellitus mimicking Mauriac syndrome. Korean J Pediatr 2015; 58: 234-7. (16 year old girl with poorly controlled diabetes presented with hepatomegaly, liver test abnormalities, cushingoid features, growth retardation and delayed puberty [ALT 459 U/L, GGT 430 U/L, HbA1c 14.3%], and glycogenosis on liver biopsy, and subsequently responded to better glycemic control with resolution of liver abnormalities followed by menarche and normal menses). 26213553
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 were attributed to an antidiabetic agent [2 metformin, 1 sitagliptin, 1 glibenclamide], but none were attributed to insulin). 25754159
Julián MT, Alonso N, Ojanguren I, Pizarro E, Ballestar E, Puig-Domingo M. Hepatic glycogenosis: An underdiagnosed complication of diabetes mellitus? World J Diabetes 2015; 6: 321-5. (Review of the definition, pathogenesis, and clinical and histological features of glycogenosis). 25789113
Ikarashi Y, Kogiso T, Hashimoto E, Yamamoto K, Kodama K, Taniai M, Torii N, et al. Four cases of type 1 diabetes mellitus showing sharp serum transaminase increases and hepatomegaly due to glycogenic hepatopathy. Hepatol Res 2017; 47 (3): E201-E209. (Four patients with poorly controlled type 1 diabetes, ages 19-29 years, developed marked increases in serum ALT [216-956 U/L] and AST [469-2763 U/L] and hepatomegaly with liver biopsies showing glycogenosis; in follow up, serum enzyme elevations improved with better glycemic control, but often worsened again with subsequent episodes of hyperglycemia). 27027269
Deemer KS, Alvarez GF. A rare case of persistent lactic acidosis in the ICU: glycogenic hepatopathy and Mauriac syndrome. Case Rep Crit Care 2016; 2016: 6072909. (18 year old woman with poorly controlled type 1 diabetes [HbA1c 11.3%] receiving intravenous glucose and insulin developed hepatomegaly and lactic acidemia [bilirubin 0.2 mg/dL, ALT 36 U/L, Alk P 120 U/L], liver biopsy showing glycogenosis, lactate levels decreasing with better diabetic control). 27699071
Umpaichitra V. Unusual glycogenic hepatopathy causing abnormal liver enzymes in a morbidly obese adolescent with well-controlled type 2 diabetes: resolved after A1c was normalized by metformin. Clin Obes 2016; 6: 281-4. (15 year old boy with severe obesity [BMI 44] and diabetes but not on insulin had raised serum ALT levels [330 rising to 467 U/L], while bilirubin and Alk P were normal and liver biopsy showed glycogenosis; enzymes improving with metformin therapy). 27400632
Satyarengga M, Zubatov Y, Frances S, Narayanswami G, Galindo RJ. Glycogenic hepatopathy: a complication of uncontrolled diabetes. AACE Clin Case Rep 2017; 3: e255-e259. (18 year old man with poorly controlled type 1 diabetes developed marked hepatomegaly [bilirubin normal, peak ALT 1049 U/L, AST 3725 U/L, glucose 1,162 mg/dL, lactate 2.4 mmol/L], biopsy showing glycogenosis and enzymes improving with better diabetic control). 28868358
Chandel A, Scarpato B, Camacho J, McFarland M, Mok S. Glycogenic hepatopathy: resolution with minimal glucose control. Case Reports Hepatol 2017; 2017: 7651387. (12 year old girl with poorly controlled type 1 diabetes developed tender hepatomegaly [bilirubin 0.2 mg/dL, ALT 356 U/L, Alk P 158 U/L], biopsy showing glycogenosis and aminotransferase levels improving with better control of diabtes). 28529811
Sherigar JM, Castro J, Yin YM, Guss D, Mohanty SR. Glycogenic hepatopathy: a narrative review. World J Hepatol 2018; 10: 172-85. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29527255) (Review of the incidence, pathogenesis, clinical features, histology, diagnosis and management of glycogenic hepatopathy, mentions that imaging by ultrasound resembles changes of nonalcoholic fatty liver disease [NAFLD], but the two conditions differ by CT, glycogenosis yielding a dense and NAFLD a bright liver image).

## OTHER REFERENCE LINKS

1. Recent References on Insulin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zileuton/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Insulin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zileuton)